# Tacrine

## OVERVIEW

### Introduction

Tacrine is an oral acetylcholinesterase inhibitor previously used for therapy of Alzheimer disease. Tacrine therapy is associated with a very high rate of serum aminotransferase elevations during therapy and has been linked to several instances of clinically apparent, acute liver injury.

### Background

Tacrine (tak' reen) was the first acetylcholinesterase inhibitor introduced into clinical use for management of Alzheimer disease. Tacrine acts by inhibiting the metabolism of acetylcholine and thus prolonging its activity and raising levels in the cerebral cortex. Therapy with tacrine improves mental functioning in patients with mild-to-moderate dementia of Alzheimer disease. Tacrine was approved for use in the United States in 1993 as therapy of mild-to-moderate dementia of the Alzheimer type. Tacrine was marketed in capsules of 10, 20, 30 and 40 mg under the brand name Cognex with the typical dose being 20 to 40 mg four times daily. Tacrine has dose limiting side effects including diarrhea, nausea, vomiting, abdominal discomfort, dizziness, headache, anxiety, blurred vision, dry mouth and insomnia, symptoms typical of cholinergic stimulation. Because of continuing concerns over safety and availability of other acetylcholinesterase inhibitors, tacrine was withdrawn from use in 2013.

### Hepatotoxicity

Strikingly, therapy with tacrine was associated with serum aminotransferase elevations in almost half of patients. These elevations usually arose within 6 to 8 weeks of starting therapy and rapidly resolved when therapy was stopped. Elevations above 3 times the upper limit of the normal range (ULN) occurred in 25%, above 10 times ULN in 6% and above 20 times ULN in 2% of patients. Accompanying elevations in alkaline phosphatase and bilirubin were rare, and the ALT abnormalities were usually asymptomatic and resolved rapidly when therapy was stopped or with dose reduction. Monitoring of serum aminotransferase levels during tacrine therapy was recommended, with dose modification for ALT elevations above 3 times the ULN and discontinuation if levels rose above 5 times the ULN. In prelicensure studies, no instances of clinically apparent acute liver injury with jaundice were reported. Subsequently, however, several cases of acute hepatocellular injury with jaundice attributed to tacrine were reported, generally arising within 2 to 8 weeks of starting therapy and usually resolving rapidly with discontinuation. Eosinophilia often accompanied the hepatic injury due to tacrine, but rash and fever were uncommon as were autoantibodies. Rechallenge often led to recurrence of the hepatic injury with a somewhat shorter latency but similar or milder course. In many patients, the serum aminotransferase elevations resolved even without drug discontinuation or dose modification. Nevertheless, fatal cases of liver injury attributed to tacrine were reported to the sponsor. Routine monitoring of serum aminotransferase levels for the first six months of therapy was recommended. However, the availability of other oral anticholinesterase inhibitors that are given only once or twice daily, do not require ALT monitoring and only rarely cause liver enzyme elevations has led to the withdrawal of tacrine from clinical use in the United States.

Likelihood score: A (well established cause of liver injury, although usually marked by serum aminotransferase elevations without symptoms or jaundice).

### Mechanism of Injury

Tacrine undergoes first pass metabolism by the liver and is extensively metabolized by the cytochrome P450 system. The hepatotoxicity of tacrine is probably related to production of a toxic intermediate, but the precise mechanism of injury is not known. Intestinal bacteria (the “microbiome”) may play a role in tacrine hepatotoxicity in that impaired glucuronidation caused by changes in intestinal bacterial flora is associated with aminotransferase elevations in rodents exposed to tacrine.

### Outcome and Management

The hepatotoxicity of tacrine is usually marked by transient and asymptomatic, moderate-to-severe elevations in serum aminotransferase levels that resolve rapidly with discontinuation. More severe instances of hepatotoxicity with symptoms and jaundice have been reported but are rare. Tacrine has not been linked to cases of chronic hepatitis or vanishing bile duct syndrome, at least in the published literature. The safety of switching to another acetylcholinesterase inhibitor after tacrine hepatotoxicity has not been shown, but there is little reason to suspect that cross sensitivity exists.

References regarding the safety and potential hepatotoxicity of the drugs used for Alzheimer disease are provided below for tacrine and again for all agents after the overview section of Alzheimer Disease Agents.

Drug Class: Alzheimer Disease Agents

## CASE REPORT

### Case 1. Acute hepatocellular injury with jaundice during tacrine therapy.(1)

A 76 year old woman developed fever and jaundice 20 days after starting tacrine in a therapeutic trial of this drug for Alzheimer disease. She had no previous history of liver disease, drug reactions, alcohol abuse or risk factors for viral hepatitis. She was taking no other medications. The dose of tacrine had been increased from 25 to 100 mg during the first 5 days of therapy, but was then reduced to 75 mg because of headaches. When jaundice was noted, tacrine was discontinued promptly and two days later she was admitted for evaluation. On examination, she was afebrile and anicteric. Blood tests showed a total serum bilirubin of 4.1 mg/dL with marked elevations in ALT (~1700 U/L) and minimal increases in alkaline phosphatase levels (~130 U/L). Liver tests had been normal before tacrine was started and were still normal on day 12 of therapy (Table). The prothrombin index was slightly decreased (70%) and eosinophil counts were normal. Tests for hepatitis A and B were negative as were autoantibodies. Ultrasound of the abdomen showed a normal liver and biliary tract. A liver biopsy showed centrilobular necrosis and mild inflammatory infiltrates with no cholestasis and no fibrosis. Serum ALT levels peaked one day after admission and fell rapidly thereafter, becoming normal within the next 5 weeks.

#### Key Points

Medication: | Tacrine (75 mg daily)
Pattern: | Hepatocellular (R=42)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 weeks
Recovery: | 5 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
-1 day | Pre | 30 | 105 | 0.7
12 days | 0 | 35 | 100 | 0.7
20 days | 0 | 1700 | 130 | 4.1 | Fever and jaundice
22 days | 0 | 2200 | 135 | 1.2 | Tacrine stopped
4 weeks | 5 days | 799 | 195 | 0.5 | Liver biopsy
5 weeks | 2 weeks | 80 | 110 | 0.6
8 weeks | 5 weeks | 30 | 95 | 0.5 | Fully recovered
Normal Values | | <40 | <130 | <1.2

* Values estimated from Figure 1.

#### Comment

Tacrine is well known to be associated with serum aminotransferase elevations which usually arise within 3 to 8 weeks of starting therapy. These elevations can be marked (>20 times ULN), but are typically self-limited and asymptomatic. This patient was unusual only because she developed jaundice and symptoms. The rapid resolution of injury upon stopping tacrine is typical. Despite the frequency of this abnormality, tacrine hepatotoxicity is usually mild and self limited. No cases of fatal tacrine induced liver injury have been reported in the literature, although such cases have evidently been reported to the sponsor.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tacrine – Cognex®

DRUG CLASS

Alzheimer Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tacrine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tacrine | 321-64-2 | C13-H14-N2

## CITED REFERENCE

1 Hammel P, Larrey D, Bernuau J, Kalafat M, Fréneaux E, Babany G, Degott C, et al. (1990). Acute hepatitis after tetrahydroaminoacridine administration for Alzheimer's disease. J Clin Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2020

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 709-42. (Expert review of hepatotoxicity published in 1999; tacrine, the first cholinesterase inhibitor approved for use in Alzheimer disease, was associated with a very high rate of serum ALT elevations [~50%], but rarely caused clinically apparent liver injury; the other Alzheimer disease agents are not discussed).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 518. (Review of hepatotoxicity of psychotropic agents ; drugs for Alzheimer disease are not specifically discussed).
Roberson ED. Alzheimer's disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 333-5. (Textbook of pharmacology and therapeutics).
Chatellier G, Lacomblez L. (1990). Tacrine (tetrahydroaminoacridine; THA) and lecithin in senile dementia of the Alzheimer type: a multicentre trial. Groupe Françs d'Etude de la Tetrahydroaminoacridine. BMJ. (In a randomized controlled crossover trial of tacrine in 67 patients with Alzheimer disease, 9 patients [13%] developed significant ALT or AST elevations, usually arising after 2-8 weeks of therapy, ALT 85-2115 U/L, one patient developed jaundice which resolved within 3-4 weeks of stopping).
Ames DJ, Bhathal PS, Davies BM, Fraser JR, Gibson PR, Roberts S. (1990). Heterogeneity of adverse hepatic reactions to tetrahydroaminoacridine. Aust N Z J Med. (5 of 14 patients [36%] taking tacrine for Alzheimer disease developed abnormal liver tests [ALT 106-422 U/L, GTT 20-71 U/L, bilirubins normal], one was symptomatic; liver biopsies showed focal necrosis, fat and one patient with granulomas; all resolved with stopping the drug or lowering the dose).
Hammel P, Larrey D, Bernuau J, Kalafat M, Fréaux E, Babany G, Degott C, et al. (1990). Acute hepatitis after tetrahydroaminoacridine administration for Alzheimer's disease. J Clin Gastroenterol. (A 76 year old woman with Alzheimer disease developed fever and jaundice 20 days after starting tacrine [bilirubin 5.0 mg/dL, ALT ~1800 U/L, Alk P 125 U/L, prothrombin index 40%], with rapid resolution on stopping, all liver tests falling to normal within 6 weeks).
O'Brien JT, Eagger S, Levy R. (1991). Effects of tetrahydroaminoacridine on liver function in patients with Alzheimer's disease. Age Ageing. (Prospective analysis of liver tests in 30 patients with Alzheimer disease treated with tacrine; 50% developed AST elevations within 17-38 days, 8 had clinical symptoms but none had jaundice, all resolved within 3-23 days after stopping or dose reduction; 6 were restarted and 5 tolerated therapy long term).
Farlow M, Gracon SI, Hershey LA, Lewis KW, Sadowsky CH, Dolan-Ureno J. (1992). A controlled trial of tacrine in Alzheimer's disease. The Tacrine Study Group. JAMA. (Among 468 patients with Alzheimer disease treated with tacrine or placebo, ALT elevations [>3 times ULN] occurred in 25% of tacrine treated, but in none of placebo treated patients; all elevations were reversible and asymptomatic, usually arising in the first 8 weeks of treatment and resolving within 7-71 days of stopping).
Knapp MJ, Knopman DS, Solomon PR, Pendlebury WW, Davis CS, Gracon SI. (1994). A 30-week randomized controlled trial of high-dose tacrine in patients with Alzheimer's disease. The Tacrine Study Group. JAMA. (In a randomized controlled trial of tacrine vs placebo in 653 patients with Alzheimer disease, some degree of ALT elevation occurred in 54% and elevations >3 times ULN in 28% of tacrine treated patients, but no patient had jaundice and most were asymptomatic, all resolved on stopping tacrine).
Watkins PB, Zimmerman HJ, Knapp MJ, Gracon SI, Lewis KW. (1994). Hepatotoxic effects of tacrine administration in patients with Alzheimer's disease. JAMA. (In depth analysis of liver test abnormalities occurring in 2446 patients on tacrine in multi-center trials; ALT elevations occurred in 49%, were >3 times ULN in 25%, >10 times ULN 6%, and >20 times ULN in 2%, usually arising within 6-8 weeks of starting, with no symptoms or minimal nausea and fatigue even when ALT >10 times ULN, eosinophilia in 23-44% but no rash, more rapid but less severe recurrence on rechallenge, nevertheless 88% could continue tacrine; more common in women than men).
Gracon SI, Knapp MJ, Berghoff WG, Pierce M, DeJong R, Lobbestael SJ, Symons J, et al. (1998). Safety of tacrine: clinical trials, treatment IND, and postmarketing experience. Alzheimer Dis Assoc Disord. (Review of safety including hepatotoxicity of tacrine based upon registration trials and postmarketing adverse event reporting; ALT levels rise to >3 times the ULN in at least 25% of patients but are usually asymptomatic and not associated with jaundice).
Barbare JC, Imbert A, Benkirane A. [Recent developments concerning drug- induced liver toxicity]. Presse Med 2001; 30: 673-6. French. PMID: 11360729 (Review of importance of central reporting of drug induced liver injury, providing examples of recently described hepatotoxic reactions, including 3 recent cases of hepatocellular injury due to riluzole).
Farlow MR, Cummings JL. (2007). Effective pharmacologic management of Alzheimer's disease. Am J Med. (Review of safety and efficacy of medications for Alzheimer disease; no discussion of hepatotoxicity).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; none were attributed to a drug used to treat Alzheimer disease).
Mayeux R. (2010). Early Alzheimer's disease. N Engl J Med. (Case discussion and review of current understanding of Alzheimer disease including role of therapy; common side effects of cholinesterase inhibitors include nausea, vomiting, anorexia, diarrhea, dizziness, muscle cramps, insomnia and vivid dreams; memantine can cause constipation, dizziness, headache and body pains; no mention of hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to drugs used to treat Alzheimer disease).
Tricco AC, Soobiah C, Berliner S, Ho JM, Ng CH, Ashoor HM, Chen MH, Hemmelgarn B, Straus SE. (2013). Efficacy and safety of cognitive enhancers for patients with mild cognitive impairment: a systematic review and meta-analysis. CMAJ. (Systematic review of 8 clinical trials and 3 reports on the safety and efficacy of Alzheimer drugs mentions that side effects of nausea, diarrhea, vomiting and headaches were usually more frequent with the active drugs compared to placebo; no mention of ALT elevations or clinically apparent liver injury).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the cases were attributed to a drug used to treat Alzheimer disease).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to a drug for Alzheimer disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were due to a drug for Alzheimer disease).
Kröger E, Mouls M, Wilchesky M, Berkers M, Carmichael PH, van Marum R, Souverein P, et al. (2015). Adverse drug reactions reported with cholinesterase inhibitors: an analysis of 16 years of individual case safety reports from VigiBase. Ann Pharmacother. (Analysis of spontaneous adverse event reports made between 2006 and 2013 to a WHO drug monitoring database identified 16,995 serious adverse events in patients receiving cholinesterase inhibitors, 121 of which were hepatobiliary, including 47 for donepezil, 53 rivastigmine and 21 galantamine; no details provided).
Mohammad D, Chan P, Bradley J, Lanctôt K, Herrmann N. (2017). Acetylcholinesterase inhibitors for treating dementia symptoms - a safety evaluation. Expert Opin Drug Saf. (Review of safety of donepezil, galantamine and rivastigmine in Alzheimer disease concludes that adverse events are “generally mild”, mostly gastrointestinal, comparable among the different agents, but usually greater with higher doses and less with transdermal formulations).
Yip LY, Aw CC, Lee SH, Hong YS, Ku HC, Xu WH, Chan JMX, et al. (2018). The liver-gut microbiota axis modulates hepatotoxicity of tacrine in the rat. Hepatology. (In Lister hooded rats, tacrine administration resulted in variable increases in ALT and AST with higher levels correlating with higher systemic exposure, which could be modified by changing the intestinal bacterial flora [microbiome], which was likely the result of bacterial deglucuronidation of tacrine during enterohepatic recycling).
Dou KX, Tan MS, Tan CC, Cao XP, Hou XH, Guo QH, Tan L, et al. (2018). Comparative safety and effectiveness of cholinesterase inhibitors and memantine for Alzheimer's disease: a network meta-analysis of 41 randomized controlled trials. Alzheimers Res Ther. (Meta-analysis of 41 published randomized controlled trials of drugs for Alzheimer disease concluded that all had beneficial effects on cognition and function but not on neuropsychiatric symptoms, and all had adverse effects but memantine showed “the best profile of acceptability”; no mention of ALT elevations or hepatotoxicity).
Khoury R, Rajamanickam J, Grossberg GT. (2018). An update on the safety of current therapies for Alzheimer's disease: focus on rivastigmine. Ther Adv Drug Saf. (Review of the safety of Alzheimer disease agents discusses gastrointestinal adverse events, cardiac side effects, skin reactions [to transdermal formulations] and neuropsychiatric effects, but not hepatic adverse events).
Bhattacharjee S, Patanwala AE, Lo-Ciganic WH, Malone DC, Lee JK, Knapp SM, Warholak T, Burke WJ. (2019). Alzheimer's disease medication and risk of all-cause mortality and all-cause hospitalization: A retrospective cohort study. PMID: Alzheimers Dement (N Y). (Among more than 20,000 Medicare beneficiaries receiving Alzheimer disease drugs, overall survival was better for those on donepezil than memantine or rivastigmine; no mention of serious hepatic adverse events or liver related deaths).
Carney G, Bassett K, Wright JM, Maclure M, McGuire N, Dormuth CR. (2019). Comparison of cholinesterase inhibitor safety in real-world practice. Alzheimers Dement (NY). (Among 29,047 Canadian patients with Alzheimer disease who initiated anticholinesterase therapy between 2007 and 2016, all cause mortality and serious cardiovascular event rates were lower in those receiving galantamine than those on donepezil; no mention of hepatic adverse events or liver related deaths).
Matsunaga S, Fujishiro H, Takechi H. (2019). Efficacy and safety of cholinesterase inhibitors for mild cognitive impairment: a systematic review and meta-analysis. J Alzheimers Dis. (Systematic review of 14 randomized controlled trials of anticholinesterase drugs in Alzheimer disease concluded that the agents had slight efficacy in ameliorating symptoms but a moderate rate of discontinuation because of adverse events such as abnormal dreams, dizziness, headache, insomnia, diarrhea, muscle cramps, nausea and weight loss; no mention of discontinuations because of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Tacrine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tacrine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tacrine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tacrine)